# Voriconazole

## OVERVIEW

### Introduction

Voriconazole is a triazole antifungal agent used primarily in the treatment or prevention of aspergillosis and candidal infections. Voriconazole therapy is associated with transient, asymptomatic serum aminotransferase elevations and is a known cause of clinically apparent acute drug induced liver injury.

### Background

Voriconazole (vor" i kon' a zole) is a synthetic triazole and a derivative of fluconazole, which is believed to act through inhibition of the fungal 14α-ergosterol demethylase that is responsible for converting lanosterol to ergosterol, which blocks cell membrane synthesis. Voriconazole has a broad spectrum of activity particularly against candida and aspergillus. Voriconazole was approved for use in the United States in 2002. Current indications include treatment of invasive aspergillosis, esophageal candidiasis and serious candidal infections. It is also used as empiric antifungal therapy in patients with neutropenia and persistent fever as well as preventive antifungal therapy in high risk individuals. Voriconazole is available as tablets of 50 and 200 mg, in an oral suspension (40 mg/mL) and in a parenteral formulation generically and under the brand name Vfend. Serious fungal infections are typically treated initially with intravenous voriconazole (4 to 6 mg/kg every 12 hours) for 3 to 10 days, followed by more prolonged therapy with oral forms (20 mg every 12 hours). Common side effects include nausea, photosensitivity, hallucinations, headache, visual disturbances and rash.

### Hepatotoxicity

Transient elevations in serum aminotransferase levels occur in 11% to 19% of patients on voriconazole. These elevations are usually asymptomatic and self-limited, but approximately 1% of patients require discontinuation of voriconazole because of ALT elevations. Clinically apparent hepatotoxicity is uncommon, but may be more frequent than with fluconazole and itraconazole. The injury arises within the first month of therapy and the pattern of serum enzyme elevations has been variable from cholestatic to hepatocellular. Several cases of acute liver failure attributed to voriconazole have been reported. Immunoallergic features and autoantibodies are uncommon. Recovery upon stopping therapy generally takes 6 to 10 weeks but, in some cases, the time to complete resolution may be prolonged.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of clinically apparent hepatotoxicity from voriconazole is unknown; however, it may have some correlation to the ability of voriconazole to alter human sterol synthesis. Because voriconazole is a substrate for several P450 enzymes (CYP 2C19, 2C9, 3A4), it has the potential to cause significant drug-drug interactions, including elevations in plasma levels of other medications that are metabolized by these P450 enzymes, sometimes resulting in toxicity. Alternatively, voriconazole plasma levels might be affected by CYP inhibitors.

### Outcome and Management

The severity of the liver injury from voriconazole ranges from mild and transient enzyme elevations to symptomatic or severe hepatitis leading to liver transplantation or death. Cases of acute liver failure have been described due to voriconazole, but not chronic liver injury or vanishing bile duct syndrome. Most cases of voriconazole hepatotoxicity resolve with discontinuation of the medication, but the improvements may be delayed and typically require 1 to 3 months. Rechallenge may lead to recurrence and should be avoided. Testing for serum bilirubin and aminotransferase levels is rercommended at the time of starting and weekly during the first month of voriconazole therapy and monthly thereafter. The relationship between voriconazole trough plasma levels of hepatotoxicity is, however, controversial. There is little information on cross reactivity of hepatic injury between voriconazole and other antifungal azoles, such as ketoconazole, itraconazole, fluconazole and posaconazole. While a few reports suggest that there is little cross reactivity, other azoles should be started with caution in patients who have suffered clinically apparent hepatotoxicity attributed to voriconazole.

Drug Class: Antifungal Agents

## CASE REPORT

### Case 1. Fulminant liver failure following voriconazole therapy in a child with AIDS.

[Modified from: Scherpbier H, Hilhorst M, Kuijpers T. Liver failure in a child receiving highly active antiretroviral therapy and voriconazole. Clin Infect Dis 2003; 37: 828-30. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12955645)]

A 10 year old with HIV infection and AIDS developed serum enzyme elevations within a day of starting voriconazole for esophageal candidiasis after failure of itraconazole, fluconazole, amphotericin B and flucytosine. Serum aminotransferase levels continued to rise and voriconazole was stopped on day 7. The patient’s liver function deteriorated rapidly even after stopping voriconazole treatment. Tests for hepatitis A, B and C were negative. Because of worsening hepatic function, her antiretroviral medications were also stopped, but her liver disease progressed to hepatic failure, coma and death 28 days after starting voriconazole.

#### Key Points

Medication: | Voriconazole
Pattern: | Hepatocellular (R=28)
Severity: | 5+ (death from hepatic failure)
Latency: | 1 day to serum aminotransferase elevations, 1 week to jaundice
Recovery: | None
Other medications: | Amprenavir, didanosine, nevirapine, lopinavir/ritonavir

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
-12 days | | 23 | 54 | 104
1 day | 0 | 53 | 127 | 113 | 0.2 | Voriconazole started
7 days | 0 | Voriconazole stopped
9 days | 2 days | 209 | 1401 | 215 | 2.0
12 days | 5 days | 553 | 5977 | - | 3.2 | Antiretrovirals stopped
16 days | 9 days | 842 | 8534 | - | 5.9
4 weeks | 3 weeks | 334 | 593 | - | 6.3 | Death
Normal Values | | <45 | <40 | <120 | <1.2

#### Comment

While there was a temporal relationship between starting voriconazole and the onset of serum aminotransferase elevations, this child was receiving several other potentially hepatotoxic agents and serum enzymes were slightly elevated before voriconazole was started. Although she had been on a stable antiretroviral regimen for many months, the voriconazole, by inhibiting CYP 3A4 activity, may have caused elevations in her antiretroviral drug levels leading to hepatotoxicity. Also unusual was the discrepancy between AST and ALT elevations which suggests muscle or heart injury as well. Nevertheless, other aspects of the case suggest the role of voriconazole in an acute hepatitis-like clinical syndrome arising within a week of starting medication. As is typical, recovery can be delayed, and the disease may progress during the 1 to 4 weeks after stopping medication.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Voriconazole – Generic, Vfend®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=voriconazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Voriconazole | 137234-62-9 | C16-H14-F3-N5-O | Image of Voriconazole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 May 2017

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999 before the availability of voriconazole).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-81. (Review of hepatotoxicity of antifungal agents ; mentions that asymptomatic elevations in liver enzymes occur in 5-15% of patients treated with voriconazole, and that life-threatening, acute hepatocellular injury have been linked to its use).
Bennett JE. Antimicrobial agents: antifungal agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-92. (Textbook of pharmacology and therapeutics; voriconazole is similar to fluconazole, but has expanded activity in vitro; it has nonlinear metabolism through CYP 2C19, 2C9 and 3A4 and plasma levels can vary greatly).
Scherpbier H, Hilhorst M, Kuijpers T. Liver failure in a child receiving highly active antiretroviral therapy and voriconazole. Clin Infect Dis 2003; 37: 828-30. (10 year old girl with AIDS on antiretroviral therapy developed ALT elevations 1 day after starting voriconazole for resistant esophageal candidiasis, requiring discontinuation of voriconazole after 7 days [bilirubin 0.3 rising to 6.3 mg/dL, ALT 23 to 209 U/L, Alk P 113 to 215 U/L], with progressive liver failure and death 28 days later: Case 1). 12955645
Walsh TJ, Lutsar I, Driscoll T, Dupont B, Roden M, Ghahramani P, Hodges M, et al. Voriconazole in the treatment of aspergillosis, scedosporiosis and other invasive fungal infections in children. Pediatr Infect Dis J 2002; 21: 240-8. (Experience in treating 69 children with invasive fungal infections with voriconazole for an average of 3 months, 8 had ALT [12%: 127-620 U/L], 5 Alk P [7%: 694-1214 U/L] and 9 bilirubin [13%: 1.7-14.8 mg/dL] elevations; 2 requiring discontinuation; no deaths from liver failure). 12005089
Denning DW, Ribaud P, Milpied N, Caillot D, Herbrecht R, Thiel E, Haas A, et al. Efficacy and safety of voriconazole in the treatment of acute invasive aspergillosis. Clin Infect Dis 2002; 34: 563-71. (Open label study with monitoring for liver injury in 137 patients with aspergillosis; 20 patients required discontinuation of voriconazole because of ALT elevations, usually during the first month; unclear whether the cases were clinically apparent or resolved with stopping). 11807679
Walsh TJ, Pappas P, Winston DJ, Lazarus HM, Petersen F, Raffalli J, Yanovich S, et al.; National Institute of Allergy and Infectious Diseases Mycoses Study Group. Voriconazole compared with liposomal amphotericin B for empirical antifungal therapy in patients with neutropenia and persistent fever. N Engl J Med 2002; 346: 225-34. (Randomized trial in 837 patients with fever and neutropenia; ALT levels rose to >5 times baseline in 7% of patients on voriconazole and 8% on amphotericin B; no clinically apparent hepatitis or acute liver failure). 11807146
Spellberg B, Rieg G, Bayer A, Edwards JE Jr. Lack of cross-hepatotoxicity between fluconazole and voriconazole. Clin Infect Dis 2003; 36: 1091-3. (32 year old man with fungal meningitis developed ALT elevations 13 days after starting fluconazole which continued to increase despite dose reduction, peaking at ALT 967 U/L, Alk P 132 U/L, but normal bilirubin; switching to voriconazole was followed by fall towards normal). 12684933
Fischer MA, Winkelmayer WC, Rubin RH, Avorn J. The hepatotoxicity of antifungal medications in bone marrow transplant recipients. Clin Infect Dis 2005; 41: 301-7. (Among 587 patients undergoing bone marrow transplantation, 123 had evidence of liver injury after transplant; case control analysis found increased rate of liver injury associated with fluconazole and amphotericin; ketoconazole, itraconazole and voriconazole were infrequently used and could not be evaluated). 16007524
Wingard J, Leather H. Hepatotoxicity associated with antifungal therapy after bone marrow transplantation. Clin Infect Dis 2005; 41: 308-10. (Editorial in response to the article by Fisher et al. [2005]; discusses the difficulties of detection, diagnosis, attribution and management of liver test abnormalities after bone marrow transplantation). 16007525
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; pooled data on 2090 patients treated with voriconazole found ALT elevations in 11% to 19%, discontinuation for ALT elevations in 1%; in addition, 19 cases [0.9%] of hepatic failure have been reported in patients receiving voriconazole in clinical trials). 15751740
Girois SB, Chapuis F, Decullier E, Revol BG. Adverse effects of antifungal therapies in invasive fungal infections: review and meta-analysis. Eur J Clin Microbiol Infect Dis 2006; 25: 138-49. (Systematic review of adverse effects of antifungal therapy in 54 studies with 9228 patients; hepatotoxicity reported in 14.1-18.6% on amphotericin, 1.9% on fluconazole, and 31.6% on itraconazole, but great variation in definitions and intensity of monitoring; voriconazole not discussed). 16622909
den Hollander JG, van Arkel C, Rijnders BJ, Lugtenburg PJ, de Marie S, Levin M-D. Incidence of voriconazole hepatotoxicity during intravenous and oral treatment for invasive fungal infections. J Antimicrob Chemother 2006; 57: 1248-50. (Retrospective analysis of 46 patients treated with iv vs oral voriconazole; 24 patients [61%] developed ALT elevations above 3 times normal, usually within first few weeks, similar with iv and oral therapy). 16556632
Husain S, Paterson DL, Studer S, Pilewski J, Crespo M, Zaldonis D, Shutt K, et al. Voriconazole prophylaxis in lung transplant recipients. Am J Transplant 2006; 6: 3008-16. (Comparison of voriconazole vs itraconazole prophylaxis against invasive fungal infections after lung transplantation; 45% of patients on voriconazole vs 15% of itraconazole developed ALT levels above 3 times normal, and discontinuation required for ALT elevations in 14% vs 7%; all ultimately resolved). 17062003
Porte L, Khatibi S, Hajj LE, Cassaing S, Berry A, Massip P, Linas MD, et al. Scedosporium apiospermum mycetoma with bone involvement successfully treated with voriconazole. Trans R Soc Trop Med Hyg 2006; 100: 891-4. (49 year old woman with Madura foot who failed to respond to multiple other antifungals had clinical response to voriconazole, but developed abnormal liver tests with Alk P 616 U/L and ALT ~2-3 times normal, but after 18 months developed abdominal pain with ALT 17 times normal and voriconazole was stopped with prompt fall of enzymes to normal). 16714039
Sambatakou H, Dupont B, Lode H, Denning DW. Voriconazole treatment for subacute invasive and chronic pulmonary aspergillosis. Am J Med 2006; 119: 527. e17-24. (32 patients with aspergillosis given voriconazole for 4-24 weeks; 13 [41%] had abnormalities of liver tests, often in first 4 weeks, two were severe, but other abnormalities resolved even on therapy). 16750972
Tan K, Brayshaw N, Tomaszewski K, Troke P, Wood N. Investigation of the potential relationships between plasma voriconazole concentrations and visual adverse events or liver function test abnormalities. J Clin Pharmacol 2006; 46: 235-43. (Prospective analysis of relationship between plasma levels of voriconazole and ALT elevations; ALT elevations occurred in 2-5% of patients and did not correlate with plasma levels, whereas AST, Alk P and bilirubin elevations did). 16432276
Levin MD, den Hollander JG, van der Holt B, Rijnders BJ, van Vliet M, Sonneveld P, van Schaik RHN. Hepatotoxicity of oral and intravenous voriconazole in relation to cytochrome P450 polymorphisms. J Antimicrob Chemother 2007; 60: 1104-7. (Among 86 patients on voriconazole, P450 polymorphisms in CYP 2C19, 2C9, and 3A5 did not correlate with individual degree of rises in bilirubin, Alk P, GGT, ALT or AST levels). 17827141
Foo H, Gottlieb T. Lack of cross-hepatotoxicity between voriconazole and posaconazole. Clin Infect Dis 2007; 45: 803-5. (70 year old man developed cholestatic liver enzyme elevations within a month of starting amphotericin and voriconazole [bilirubin normal, Alk P 1210 U/L, ALT 104 U/L], which fell towards normal when switched to posaconazole). 17712772
Eiden C, Peyrière H, Cociglio M, Djezzar S, Hansel S, Blayac J, Hillaire-Buys D. Adverse effects of voriconazole: analysis of the French pharmacovigilance database. Ann Pharmacother 2007; 41: 755-63. (In first 4 years of use of voriconazole in France, 227 adverse events were reported to a Federal registry, including 52 hepatic events, usually serum aminotransferase elevations only; 2 deaths). 17456542
Howard A, Hoffman J, Sheth A. Clinical application of voriconazole concentrations in the treatment of invasive aspergillosis. Ann Pharmacother 2008; 42: 1859-64. (Review of literature on usefulness of monitoring voriconazole drug levels both for efficacy and safety). 19017830
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, two cases were attributed to fluconazole, and one to ketoconazole, one to itraconazole, none to voriconazole). 18955056
Neely M, Rushing T, Kovacs A, Jelliffe R, Hoffman J. Voriconazole pharmacokinetics and pharmacodynamics in children. Clin Infect Dis 2010; 50: 27-36. (Among 46 children treated wtih voriconazole in various doses, 10 had ALT elevations on therapy, peaking at 63 days at an average of 8 fold baseline; no information on outcome or clinical features of injury; no correlation of ALT elevations with drug levels). 19951112
Cadena J, Levine DJ, Angel LF, Maxwell PR, Brady R, Sanchez JF, Michalek JE, et al. Antifungal prophylaxis with voriconazole or itraconazole in lung transplant recipients: hepatotoxicity and effectiveness. Am J Transpl 2009; 9: 2085-91. (Retrospective analysis of safety of prophylaxis with voriconazole and inhaled amphotericin B [35 patients] vs itraconazole [32] in lung transplant recipients; 12 voriconazole but no itraconazole treated patients developed liver injury; details not provided). 19645709
Ueda K, Nannya Y, Kumano K, Hangaishi A, Takahashi T, Imai Y, Kurokawa M. Monitoring trough concentration of voriconazole is important to ensure successful antifungal therapy and to avoid hepatic damage in patients with hematological disorders. Int J Hematol 2009; 89: 592-9. (Liver enzyme elevations occurred only with voriconazole levels over 6 mg/L). 19340528
Matsumoto K, Ikawa K, Abematsu K, Fukunaga N, Nishida K, Fukamizu T, Shimodozono Y, et al. Correlation between voriconazole trough plasma concentration and hepatotoxicity in patients with different CYP2C19 genotypes. Int J Antimicrob Agents. 2009; 34: 91-4. (Study of effect of CYP2C19 polymorphism on the relationship between voriconazole trough concentrations and hepatotoxicity in 29 Japanese patients with fungal infections; 10 [34.5%] of 29 patients with ≥3.9 mg/L developed liver enzyme elevations). 19261446
Björnsson E, Davidsdottir L. The long-term follow-up after idiosyncratic drug-induced liver injury with jaundice. J Hepatol 2009; 50: 511-7. (In long term follow up of 685 patients with drug induced liver injury in Sweden, 8 were found to have developed cirrhosis, 5 of whom died including a 34 year old man with fluconazole hepatotoxicity who died 4 years later of complications of cirrhosis, possibly alcoholic). 19155082
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; voriconazole is similar in activity to itraconazole; serum concentrations can accumulate and should be monitored, drug-drug interactions are common). 19940816
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials in more than 8000 patients, found liver enzyme elevations in 19.7% of patients on voriconazole, but few patients had to stop therapy for this reason; rate for itraconazole was 18.9%, fluconazole 10%). 20308378
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, voriconazole ranked 21st with 52 cases [odds ratio 10.7] and fluconazole 30th with 42 cases [odds ratio 8.6]; no other antifungal agent listed in the top 40 causes). 21039766
Amigues I, Cohen N, Chung D, Seo SK, Plescia C, Jakubowski A, Barker J, et al. Hepatic safety of voriconazole after allogeneic hematopoietic stem cell transplantation. Biol Blood Marrow Transplant 2010; 16: 46-52. (Retrospective review of 200 stem cell transplant recipients treated with voriconazole; 34% developed ALT or AST elevations >3 times ULN, but none had clinically apparent liver injury, liver failure or died). 20053331
Alffenaar JW, van Assen S, de Monchy JG, Uges DR, Kosterink JG, van der Werf TS. Intravenous voriconazole after toxic oral administration. Antimicrob Agents Chemother 2010; 54: 2741-2. (58 year old man with invasive aspergillosis developed liver test abnormalities 3 months after starting oral voriconazole accompanied by erythematous blistering rash that resolved with stopping drug and, neverthelss, did not recur with administration of intravenous voriconazole). 20385853
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 6 due to antifungal agents including 3 due to terbinafine, 2 to ketaconazole and one to itraconazole, but none to vorconazole). 20949552
Gorski E, Esterly JS, Postelnick M, Trifilio S, Fotis M, Scheetz MH. Evaluation of hepatotoxicity with off-label oral-treatment doses of voriconazole for invasive fungal infections. Antimicrob Agents Chemother 2011; 55: 184-9. (Among 109 patients with suspected invasive fungal infections treated with voriconazole for at least 7 days, higher doses were associated with more frequent Alk P, but not ALT or bilirubin levels; elevations above 3 times ULN of bilirubin occurring in 9%, ALT in 15%, and Alk P in 17% of patients). 20974867
Belaiche S, Roustit M, Bedouch P, Quetant S, Saint-Raymond C, Pison C. Management of voriconazole hepatotoxicity in a lung transplant patient. Transpl Infect Dis 2011 ; 13: 309-11. (46 year old woman with lung transplant and persistent pulmonary aspergillosis developed rising ALT and Alk P levels without symptoms 10 days after starting voriconazole [bilirubin not given, ALT 223 U/L, Alk P 369 U/L], which resolved with reduction of the voriconazole dose, allowing for long term therapy). 21176020
Antifungal drugs. Treat Guidel Med Lett 2012;10: 61-8. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; side effects include blurred vision, photophobia, fever, nausea, rash, photosensitivity, Stevens-Johnson syndrome, periostitis, confusion, anaphylactoid infusion reactions, and increased "transaminase levels"). 22825657
Saito T, Fujiuchi S, Tao Y, Sasaki Y, Ogawa K, Suzuki K, Tada A, et al; NHO Pulmonary Fungosis Research Group. Efficacy and safety of voriconazole in the treatment of chronic pulmonary aspergillosis: experience in Japan. Infection 2012; 40: 661-7. (Among 77 patients with chronic pulmonary aspergillosis treated wtih voriconazole, 12 [16%] developed liver test abnormalities and 2 required drug discontinuation; no details given). 22956473
Luong ML, Hosseini-Moghaddam SM, Singer LG, Chaparro C, Azad S, Lazar N, Boutros PC, et al. Risk factors for voriconazole hepatotoxicity at 12 weeks in lung transplant recipients. Am J Transplant 2012; 12: 1929-35. (Among 105 lung transplant recipients treated with voriconazole, 54 [51%] developed hepatotoxicity which led to discontinuation in 36 [34%], with a median time to onset of 14 days [range 7 to 84 days]). 22486950
Mitsani D, Nguyen MH, Shields RK, Toyoda Y, Kwak EJ, Silveira FP, Pilewski JM, et al. Prospective, observational study of voriconazole therapeutic drug monitoring among lung transplant recipients receiving prophylaxis: factors impacting levels of and associations between serum troughs, efficacy, and toxicity. Antimicrob Agents Chemother 2012; 56: 2371-7. (Among 93 patients with lung transplanted treated prophylactically with voriconazole for at least 3 months, plasma trough levels correlated with efficacy, but not toxicity; 10 patients had ALT elevations above 5 times ULN, but no mention of clinically apparent liver injury). 22330924
Chu HY, Jain R, Xie H, Pottinger P, Fredricks DN. Voriconazole therapeutic drug monitoring: retrospective cohort study of the relationship to clinical outcomes and adverse events. BMC Infect Dis 2013; 13: 105. (Among 108 patients treated with voriconazole for invasive fungal infections, plasma levels ranged widely but did not correlate with clinical outcomes or hepatotoxicity, 15% had ALT elevations above 5 times ULN or Alk P elevations above 3 times ULN). 23442261
Solís-Muñoz P, López JC, Bernal W, Willars C, Verma A, Heneghan MA, Wendon J, et al. Voriconazole hepatotoxicity in severe liver dysfunction. J Infect 2013; 66: 80-6. (Among 29 patients with severe liver disease treated with voriconazole for suspected invasive aspergillosis, 20 [69%] developed increases in serum enzymes during treatment, but none developed acute liver failure). 23041040
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to voriconazole or other antifungal agents). 23419359
Suzuki Y, Tokimatsu I, Sato Y, Kawasaki K, Sato Y, Goto T, Hashinaga K, et al. Association of sustained high plasma trough concentration of voriconazole with the incidence of hepatotoxicity. Clin Chim Acta 2013; 424: 119-22. (Among 39 Japanese patients treated with voriconazole, 11 developed ALT elevations, which were more frequent among those with higher voriconazole trough levels). 23747486
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral anti-fungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. (Analysis of Taiwan National Health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents, including 28 [54%] due to ketoconazole, 12 fluconazole, 8 griseofulvin, 3 itraconazole, 2 terbinafine, but voraconazole was not included in the analysis). 23750489
Zonios D, Yamazaki H, Murayama N, Natarajan V, Palmore T, Childs R, Skinner J, et al. Voriconazole metabolism, toxicity, and the effect of cytochrome P450 2C19 genotype. J Infect Dis 2014; 209: 1941-8. (Among 95 patients treated with voriconazole between 2005 and 2007 at the NIH Clinical Center, drug levels were highly variable and ALT elevations leading to discontinuation occurred in 6 patients, usually arising within 7 days, ALT rising to peak of 137 to 1064 U/L, one with jaundice and recurrence on rechallenge with voriconazole, but not posa- or flu-conazole). 24403552
Raschi E, Poluzzi E, Koci A, Caraceni P, Ponti FD. Assessing liver injury associated with antimycotics: Concise literature review and clues from data mining of the FAERS database. World J Hepatol 2014; 6: 601-12. (Analysis of the FDA database on adverse reactions [2004 to 2011] identified 68,115 reports of liver injury including 1964 due to antifungal agents, the most common being terbinafine [422], fluconazole [412], voriconazole [361], amphotericin B [265], itraconazole [182], ketaconazole [94] and posaconazole [70]; among 112 cases with acute liver failure with, the major causes were fluconazole [31], terbinafine [27], and voriconazole [19]). 25232453
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 cases [1.6%] were attributed to antifungal agents including 6 triazoles [3 with jaundice and 2 hospitalized, no deaths], 4 due to fluconazole, 1 ketoconazole and 1 voriconazole). 25754159
Lo Re V 3rd, Carbonari DM, Lewis JD, Forde KA, Goldberg DS, Reddy KR, Haynes K, et al. Oral azole antifungal medications and risk of acute liver injury, overall and by chronic liver disease status. Am J Med 2016; 129: 283-91. (Among 478 persons treated with oral vorconazole analyzed from a Kaiser Permanente clinical database, the incidence of ALT or AST elevations above 200 U/L was 18.2% and severe acute liver injury 1.7%; rates that were an order of magnitude higher than those with fluconazole, ketoconazole and itraconazole). 26597673
Lopez JL, Tayek JA. Voriconazole-induced hepatitis via simvastatin- and lansoprazole-mediated drug interactions: a case report and review of the literature. Drug Metab Dispos 2016; 44: 124-6. (44 year old man taking voriconazole for more than a year developed jaundice within 10 days of starting lansoprazole [bilirubin 13.0 mg/dL, ALT 362 U/L, Alk P 406 U/L], which resolved on stopping but recurred 16 months later two weeks after starting simvastatin [bilirubin 15.4 mg/dL, ALT 893 U/L, Alk P 789 U/L], resolving rapidly on stopping; authors hypothesize that voriconazole was the cause of the liver injury, its plasma levels being affected by effects of the lanosprazole and simvastatin on drug metabolism). 26502771
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity and discusses fluconazole, itraconazole, voriconazole, posaconazole and isavuconazole, but not ketoconazole). 27927037

## OTHER REFERENCE LINKS

1. Recent References on Voriconazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(voriconazole)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Voriconazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=voriconazole)